# Ranolazine

## OVERVIEW

### Introduction

Ranolazine is a unique, orally available antiangina agent. Chronic ranolazine therapy has not been associated with serum enzyme elevations, but has been linked to rare cases of mild, clinically apparent liver injury.

### Background

Ranolazine (ra nol' a zeen) is a piperazine derivative which has unique activity against symptoms of angina pectoris. Its mechanism of action is unclear, but is believed to involve inhibition of fatty acid oxidation and blockage of the inward sodium currents in cardiomyocytes which reduces intracellular calcium accumulation and improves left ventricular function. Unlike other antiangina agents, ranolazine does not decrease heart rate, blood pressure or vascular resistance. In multiple clinical trials, extended release formulations of ranolazine were shown to reduce angina attacks and prolong exercise tolerance in patients with coronary artery disease. It also appears to have some degree of antiarrhythmia activity. Ranolazine was approved for use in the United States in 2006 and current indications are for chronic angina, either alone or in combination with other angina medications (such as beta blockers or calcium channel blockers). Ranolazine is available in extended release tablets of 500 and 1000 mg generically and under the trade name Ranexa. The typical dose is 500 to 1000 mg twice daily. Ranolazine is generally well tolerated, but side effects can include fatigue, weakness, dizziness, headache, nausea and constipation. Higher doses may be associated with syncope, prolongation of the QTc interval and renal dysfunction.

### Hepatotoxicity

In large preregistration clinical trials, ranolazine was not associated with serum aminotransferase and alkaline phosphatase elevations during treatment and no instances of symptomatic acute liver injury were reported. Since its approval and more wide spread use, ranolazine has been linked to a single instance of mildly symptomatic, rapidly reversible, anicteric liver injury (Case 1). Immunoallergic and autoimmune features were not present. Recovery was rapid once ranolazine was discontinued.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which ranolazine might cause liver injury is not clear. It is extensively metabolized in the liver largely via CYP 3A4 and is susceptible to drug-drug interactions. Inhibitors of CYP 3A4 cause increase the ranolazine levels while inducers (such as rifampin) cause reduced serum levels of ranolazine.

### Outcome and Management

The hepatic injury reported to be caused by ranolazine has been mild and rapidly reversible upon withdrawal of the agent. Ranolazine has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no evidence that there is cross sensitivity to hepatic injury between ranolazine and other oral antiangina or antiarrhythmic agents.

Drug Class: Antiangina Agents

## CASE REPORT

### Case 1. Mild anicteric hepatitis attributed to ranolazine.

[Modified from: Sancho-del-Val L, Barrio-Andrés J, Herranz-Bachiller MT, Alcaide-Suárez N. Hepatotoxicity and insomnia secondary to ranolazine. Rev Esp Enferm Dig 2013; 105: 304-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23971665)]

A 63 year old woman with hypertension and angina pectoris developed fatigue and insomnia 3 months after starting ranolazine (375 mg every 8 hours). She had no history of liver disease, risk factors for viral hepatitis or history of alcohol abuse. Her other medications included bisoprolol, amlodipine and atorvastatin. Initially, her serum bilirubin was 0.6 mg/dL, ALT 201 U/L, AST 97 U/L, GGT 213 U/L and alkaline phosphatase 150 U/L. Tests for hepatitis B and C were negative as were routine autoantibodies. An abdominal ultrasound was normal. Ranolazine was stopped and liver tests were normal when tested two months later.

#### Key Points

Medication: | Ranolazine (375 mg every 12 hours)
Pattern: | Mixed (R=4.5)
Severity: | 1+ (no jaundice, mild symptoms)
Latency: | 3 months
Recovery: | Within 2 months
Other medications: | Bisoprolol, amlodipine, atorvastatin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
3 months | 0 | 201 | 150 | 0.6 | Fatigue, insomnia
5 months | 2 months | 46 | 75
Normal Values | | <35 | <120 | <1.2

#### Comment

A woman with unstable angina developed fatigue 3 months after starting ranolazine and was found to have mild elevations in serum aminotransferase and alkaline phosphatase levels. These were normal or near normal two months after stopping the ranolazine. She has also taking other antiangina and cholesterol lowering agents, but these were evidently continued. Fatigue is a not uncommon side effect of ranolazine and attribution of fatigue to the liver enzyme elevations cannot be made with complete assurance. The case report was somewhat sparsely documented, but suggests that ranolazine can cause mild liver enzyme elevations that may be accompanied by constitutional symptoms. The injury was, however, quite mild and resolved rapidly upon stopping ranolazine.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ranolazine – Ranexa®

DRUG CLASS

Antiangina Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ranolazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ranolazine | 95635-55-5 | C24-H33-N3-O4 | Ranolazine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 May 2018

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999 before the availability of ranolazine).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular drugs; ranolazine is not discussed).
Michel T, Hoffman BB. Treatment of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics).
Thadani U, Ezekowitz M, Fenney L, Chiang YK. Double-blind efficacy and safety study of a novel anti-ischemic agent, ranolazine, versus placebo in patients with chronic stable angina pectoris. Ranolazine Study Group. Circulation 1994; 90: 726-34. (Among 318 patients with angina pectoris treated with intermediate release ranolazine [30, 60 or 120 mg] or placebo 3 times daily for 4 weeks, exercise tolerance was not different in the 4 groups and side effects included headaches, dizziness and fatigue while differences in laboratory tests were not “clinically significant”). 8044941
Pepine CJ, Wolff AA. A controlled trial with a novel anti-ischemic agent, ranolazine, in chronic stable angina pectoris that is responsive to conventional antianginal agents. Ranolazine Study Group. Am J Cardiol. 1999; 84: 46-50. (Among 312 patients with angina pectoris treated with intermediate release ranolazine [600, 800 or 1200 mg daily] or placebo, exercise tolerance improved compared to placebo at peak plasma levels and the only side effects were mild gastrointestinal upset; there were “no significant changes in…clinical laboratory blood tests”). 10404850
Chaitman BR, Pepine CJ, Parker JO, Skopal J, Chumakova G, Kuch J, Wang W, et al.; Combination Assessment of Ranolazine In Stable Angina (CARISA) Investigators. Effects of ranolazine with atenolol, amlodipine, or diltiazem on exercise tolerance and angina frequency in patients with severe chronic angina: a randomized controlled trial. JAMA 2004; 291: 309-16. (Among 823 patients with symptomatic angina despite antianginal medications who were treated with ranolazine [750 or 100 mg] or placebo twice daily for 12 weeks, exercise tolerance was increased with ranolazine; the most common side effects were constipation, dizziness, nausea and fatigue; no mention of ALT changes or hepatotoxicity). 14734593
Chaitman BR. Efficacy and safety of a metabolic modulator drug in chronic stable angina: review of evidence from clinical trials. J Cardiovasc Pharmacol Ther 2004; 9 Suppl 1: S47-64. (Review of the efficacy and safety of sustained release ranolazine which results in significant improvement in angina and has modest side effects such as fatigue, dizziness, nausea and constipation and rarely syncope; “ranolazine does not cause deleterious changes in laboratory parameters”). 15378131
Ranolazine (ranexa) for chronic angina. Med Lett Drugs Ther 2006; 48 (1236): 46-7. (Concise review of pharmacology, clinical efficacy, safety and costs of ranolazine shortly after its approval in the US; mentions side effects of constipation, nausea, dizziness and headache, but does not mention ALT elevations or hepatotoxicity). 16770296
Koren MJ, Crager MR, Sweeney M. Long-term safety of a novel antianginal agent in patients with severe chronic stable angina: the Ranolazine Open Label Experience (ROLE). J Am Coll Cardiol 2007; 49: 1027-34. (Among 746 patients with chronic angina treated with ranolazine [500 to 1000 mg twice daily] in an open label extension study for an average of 2.8 years, the drug was well tolerated and there was no mention of ALT elevations or clinically apparent liver injury). 17349881
Morrow DA, Scirica BM, Karwatowska-Prokopczuk E, Murphy SA, Budaj A, Varshavsky S, Wolff AA, et al.; MERLIN-TIMI 36 Trial Investigators. Effects of ranolazine on recurrent cardiovascular events in patients with non-ST-elevation acute coronary syndromes: the MERLIN-TIMI 36 randomized trial. JAMA 2007; 297: 1775-83. (Among 6580 patients with acute coronary syndrome treated with ranolazine [1000 mg twice daily] or placebo, there were no differences in acute or one year mortality and adverse events included dizziness [13% vs 7%], nausea [9% vs 6%], constipation [9% vs 3%] and syncope [3.3% vs 2.3%]; no mention of ALT elevations or hepatotoxicity). 17456819
Miles RH, Passman R, Murdock DK. Comparison of effectiveness and safety of ranolazine versus amiodarone for preventing atrial fibrillation after coronary artery bypass grafting. Am J Cardiol 2011; 108: 673-6. (Among 393 patients undergoing bypass grafting who were treated with either amiodarone or ranolazine for 14 days, there was a higher rate of atrial fibrillation with ranolazine [26.5% vs 17.5%]; no mention of changes in ALT levels during therapy). 21726841
Sendón JL, Lee S, Cheng ML, Ben-Yehuda O; CARISA study investigators. Effects of ranolazine on exercise tolerance and angina frequency in patients with severe chronic angina receiving maximally-tolerated background therapy: analysis from the Combination Assessment of Ranolazine In Stable Angina (CARISA) randomized trial. Eur J Prev Cardiol 2012; 19: 952-9. (In a post hoc analysis of a trial of 2 doses of ranolazine vs placebo in patients with chronic angina [Chaitman 2004] focusing upon patients receiving the maximally tolerated dose, ranolazine decreased angina symptoms and adverse events were similar to what has been previously published). 22689417
Sancho-del-Val L, Barrio-Andrés J, Herranz-Bachiller MT, Alcaide-Suárez N. Hepatotoxicity and insomnia secondary to ranolazine. Rev Esp Enferm Dig 2013; 105: 304-5. (63 year old woman with angina developed fatigue and serum enzyme elevations without jaundice 3 months after starting ranolazine, symptoms and liver tests improving once the drug was stopped: Case 1). 23971665
Aldakkak M, Stowe DF, Camara AK. Safety and efficacy of ranolazine for the treatment of chronic angina pectoris. Clin Med Insights Ther 2013; 2013: 1-14. (Review of safety and efficacy of ranolazine as therapy of angina discusses common side effects of dizziness, nausea, constipation, headache and fatigue and minor laboratory changes such as increases in creatinine and eosinophils and decreases in hematocrit and HbA1c levels; no mention of changes in ALT or hepatotoxicity). 24574825
De Ferrari GM, Maier LS, Mont L, Schwartz PJ, Simonis G, Leschke M, Gronda E, et al.; RAFFAELLO Investigators. Ranolazine in the treatment of atrial fibrillation: Results of the dose-ranging RAFFAELLO study. Heart Rhythm 2015; 12: 872-8. (Among 238 patients undergoing cardioversion for atrial fibrillation treated with ranolazine [375, 500 or 750 mg twice daily] or placebo, the 2 higher doses reduced recurrence of fibrillation; side effects included fatigue [16-17% vs 9% with placebo] and there were no liver related serious adverse events and “no significant changes in safety laboratory tests”). 25602175
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to ranolazine). 25754159
Alexopoulos D, Kochiadakis G, Afthonidis D, Barbetseas J, Kelembekoglou P, Limberi S, Spanos A, et al. Ranolazine reduces angina frequency and severity and improves quality of life: Observational study in patients with chronic angina under ranolazine treatment in Greece (OSCAR-GR). Int J Cardiol 2016; 205: 111-6. (Among 189 patients with chronic angina treated with ranolazine for 6 months, angina symptoms decreased and quality of life indices improved, while side effects were usually mild and “no adverse events involving routine laboratory values were reported”). 26730841
Olivotto I, Camici PG, Merlini PA, Rapezzi C, Patten M, Climent V, Sinagra G, et al. Efficacy of ranolazine in patients with symptomatic hypertrophic cardiomyopathy: the RESTYLE-HCM randomized, double-blind, placebo-controlled study. Circ Heart Fail 2018; 11: e004124. (Among 80 adults with hypertrophic cardiomyopathy treated with ranolazine or placebo for 5 months, ranolazine had no overall effect on exerice performance or quality of life, but was well tolerated with similar rates of adverse events as with placebo and ALT elevations in only one treated subject). 29321131

## OTHER REFERENCE LINKS

1. Recent References on Ranolazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zileuton/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ranolazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zileuton)